# Brigatinib

## OVERVIEW

### Introduction

Brigatinib is a tyrosine kinase receptor inhibitor and antineoplastic agent used in the therapy of selected forms of advanced non-small cell lung cancer. Brigatinib is associated with a high rate of transient elevations in serum aminotransferase levels during therapy and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Brigatinib (bri ga' ti nib) is a small molecule tyrosine kinase receptor inhibitor with potent activity against anaplastic lymphoma kinase (ALK) that is rearranged and mutated in some cancers including approximately 5% of non-small cell lung cancer (NSCLC). The mutated, rearranged ALK promotes unregulated cell growth and proliferation. Brigatinib has been found to inhibit mutated ALK in cell culture and in several clinical trials was found to induce objective responses in a proportion of patients with refractory, advanced NSCLC that are ALK-positive. Brigatinib was approved for use in the United States in 2017 in patients with ALK-positive, metastatic NSCLC who have progressed despite therapy with first generation ALK inhibitors (such as crizotinib), and the indication was broadened in 2020 to include initial therapy of ALK-positive metastatic NSCLC. Brigatinib is available in tablets of 30, 90 and 180 mg under the brand name Alunbrig. The usual adult dose is 180 mg once daily, after a 7 day lead-in period at 90 mg daily, continued until disease progression or intolerable toxicity occurs. Side effects are common and can be dose limiting. Common adverse events include fatigue, nausea, diarrhea, cough, headache, rash and elevations in serum creatine kinase, lipase, and amylase. Less common but potentially severe side effects include interstitial lung disease and pneumonitis, hypertension, bradycardia, visual disturbance, muscle injury, hyperglycemia, photosensitivity and embryo-fetal toxicity.

### Hepatotoxicity

In preregistration trials of brigatinib, ALT elevations occurred in up to 40% of patients but values above 5 times the upper limit of normal (ULN) were found in only 1% to 3%. Brigatinib therapy was also associated with frequent elevations in alkaline phosphatase (15% to 29%), but the serum enzyme elevations were usually mild-to-moderate in degree as well as asymptomatic and transient in nature. In subsequent controlled trials of brigatinib as initial therapy of ALK positive NSCLC, ALT elevations were more frequent, occurring in 52% of patients with levels above 5 times ULN in 5%. Alkaline phosphatase elevations arose in 36% of brigatinib treated patients and were above 5 times ULN in 3%, but these abnormalities were largely transient and asymptomatic.

Clinically apparent liver injury with jaundice was not reported in the prelicensure studies of brigatinib. Since its approval only a single case of suspected liver injury has been reported with brigatinib. In contrast, several instances of acute liver injury have been reported with crizotinib, alectinib and ceritinib. Thus, clinically apparent liver injury due to brigatinib must be very rare if it occurs at all.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Serum enzyme and bilirubin elevations are frequent during therapy with tyrosine kinase inhibitors, but their cause is unknown. The liver injury may be due to direct activity against essential intracellular kinases or to production of a toxic intermediate during its metabolism. Brigatinib is metabolized in the liver predominantly by CYP 3A4 and is susceptible to drug-drug interactions with strong inhibitors or inducers of this microsomal enzyme.

### Outcome and Management

Serum aminotransferase elevations are common during brigatinib therapy but rarely lead to symptoms or jaundice, and brigatinib has not but has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. The product label includes a warning about hepatotoxicity and recommends measuring routine liver tests before starting brigatinib and during treatment, particularly during the first 3 months. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks of if symptoms or jaundice arise. There appears to be little cross sensitivity to liver injury among the ALK inhibitors, and patients who have stopped brigatinib because of liver test abnormalities might be switched to another ALK inhibitor but only with careful monitoring.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brigatinib – Alunbrig®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brigatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Brigatinib | 1197953-54-0 | C29-H39-Cl-N7-O2-P | SID: 251846332

## ANNOTATED BIBLIOGRAPHY

References updated: 18 August 2026

Abbreviations: ALK, anaplastic lymphoma kinase; NSCLC, non-small cell lung cancer; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013; discusses the hepatotoxicity of crizotinib but not alectinib or ceritinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Shaw AT, Engelman JA. ALK in lung cancer: past, present, and future. J Clin Oncol 2013; 31: 1105-11. (Review of the history of discovery of ALK mutations and development of crizotinib as therapy of NSCLC patients with this mutation as well as next generation ALK inhibitors in development; no discussion of hepatotoxicity or ALT elevations). 23401436
Gettinger SN, Bazhenova LA, Langer CJ, Salgia R, Gold KA, Rosell R, Shaw AT, et al. Activity and safety of brigatinib in ALK-rearranged non-small-cell lung cancer and other malignancies: a single-arm, open-label, phase 1/2 trial. Lancet Oncol 2016; 17: 1683-96. (Among 137 patients with NSCLC [n=79] and other cancers treated with varying doses of brigatinib, objective responses were found in 75% of those with NSCLC and ALK rearrangements and adverse events were dose related, ALT elevations arising in 15 [11%] and to levels above 5 times ULN in 2 patients [1.5%]). 27836716
Markham A. Brigatinib: first global approval. Drugs 2017; 77 (10): 1131-5. (Review of the development, chemical structure, mechanism of action, pharmacology, clinical efficacy and safety of brigatinib soon after its accelerated approval in the US; mentions that ALT elevations rise in 34-40% of patients). 28597393
Kim DW, Tiseo M, Ahn MJ, Reckamp KL, Hansen KH, Kim SW, Huber RM, et al. Brigatinib in patients with crizotinib-refractory anaplastic lymphoma kinase-positive non-small-cell lung cancer: a randomized, multicenter phase II trial. J Clin Oncol 2017; 35: 2490-8. (Among 222 patients with refractory ALK-positive NSCLC treated with two different regimens of brigatinib the overall objective response rate was 45% and adverse events included nausea, diarrhea, fatigue, cough and acute severe pulmonary symptoms [6%]; serum AST elevations arose in 11% of patients). 28475456
Costa RB, Costa RLB, Talamantes SM, Kaplan JB, Bhave MA, Rademaker A, Miller C, et al. Systematic review and meta-analysis of selected toxicities of approved ALK inhibitors in metastatic non-small cell lung cancer. Oncotarget 2018; 9: 22137-46. (Analysis of the literature on toxicity of ALK inhibitors approved for use in ALK-positive NSCLC [alectinib, brigatinib, ceritinib and crizotinib] found high rates of adverse events with all four [97-99%] including any ALT elevations [14-47%] and ALT elevations above 5 times ULN [4-23%]). 29774128
Brigatinib (Alunbrig) for non-small cell lung cancer. Med Lett Drugs Ther 2018; 60 (1545): e72-e73. (Concise review of the mechanism of action, clinical efficacy, safety and costs of brigatinib soon after its approval for use in the US; does not mention ALT elevations or hepatotoxicity). 29667950
Camidge DR, Kim HR, Ahn MJ, Yang JC, Han JY, Lee JS, Hochmair MJ, et al. Brigatinib versus crizotinib in ALK-positive non-small-cell lung cancer. N Engl J Med 2018; 379: 2027-39. (Among 275 patients with previously untreated, ALK-positive NSCLC treated with brigatinib [180 mg daily] or crizotinib [250 mg twice daily], the estimated 12 month progression free survival was greater with brigatinib [67% vs 43%] and ALT elevations were less frequent [any elevations 19% vs 32% and those above 5 times ULN 1% vs 9%], ALT elevations leading to dose reduction in 1% vs 6%, and no case of clinically apparent liver injury with jaundice was reported with either). 30280657
Huber RM, Hansen KH, Paz-Ares Rodriguez L, West HL, Reckamp KL, Leighl NB, Tiseo M, et al. Brigatinib in crizotinib-refractory ALK+ NSCLC: 2-year follow-up on systemic and intracranial outcomes in the phase 2 ALTA trial. J Thorac Oncol 2020; 15: 404-15. (Among 222 patients with crizotinib-refractory, ALK-positive NSCLC treated with brigatinib in two dose regimens with 2 year follow up, median progression free survival 9 vs 17 months, and no new safety findings emerged, with no instances of clinically apparent liver injury). 31756496
Camidge DR, Kim HR, Ahn MJ, Yang JCH, Han JY, Hochmair MJ, Lee KH, et al. Brigatinib versus crizotinib in advanced ALK inhibitor-naive ALK-positive non-small cell lung cancer: second interim analysis of the phase III ALTA-1L trial. J Clin Oncol 2020; 38: 3592-603. (In a 2 year follow up of a controlled trial of brigatinib vs crizotinib in 275 patients with ALK-positive NSCLC [Camidge 2018], median progression free survival was 24 vs 11 months and ALT elevations arose in 25% vs 35% with values above 5 times ULN in 4% vs 10%; dose reductions of brigatinib for adverse events 40% of patients but only 1-2% for ALT or AST elevations). 32780660
Urbanska EM, Santoni-Rugiu E, Melchior LC, Carlsen JF, Sorensen JB. Intracranial response of ALK+ non-small-cell lung cancer to second-line dose-escalated brigatinib after alectinib discontinuation due to drug-induced hepatitis and relapse after whole brain radiotherapy followed by stereotactic radiosurgery. Clin Lung Cancer 2021; 22: e528-e532. (35 year old woman with ALK-positive NSCLC developed persistent aminotransferase elevations 6 months after starting alectinib that did not improve upon stopping [ALT 219 rising to 474 U/L] and was treated with high doses of prednisone and brigatinib after appearance of brain metastasis without recurrence of ALT elevations). 32651064
Zhou Z, Wang C, Ying L, Jin M, Zhang F, Shi D. Anaplastic lymphoma kinase tyrosine kinase inhibitor-induced hepatic failure in lung cancer patients: a study of signal mining and analysis of the FDA adverse event reporting system database. J Clin Pharm Ther 2021; 46: 1148-54. (Analysis of adverse event reports submitted to the FDA’s Adverse Event Reporting System [FAERS] between 2013 and 2019 found disproportionate reporting of hepatic failure with alectinib, ceritinib, and crizotinib but not with brigatinib). 33768534
Camidge DR, Kim HR, Ahn MJ, Yang JCH, Han JY, Hochmair MJ, Lee KH, et al. Brigatinib versus crizotinib in ALK inhibitor-naive advanced ALK-positive NSCLC: final results of phase 3 ALTA-1L trial. J Thorac Oncol 2021; 16: 2091-2108. (In the controlled trial of brigatinib vs crizotinib in 275 patients with ALK-positive NSCLC [Camidge 2018], median progression free survival at 3 years was 43% vs 19%, and ALT elevations arose in 23% vs 36%, were above 5 time ULN in 4% vs 10%, and required dose modification in 1% vs 6%; while no instances of clinically apparent liver injury were reported). 34537440
Ou SI, Nishio M, Ahn MJ, Mok T, Barlesi F, Zhou C, Felip E, et al. Efficacy of brigatinib in patients with advanced ALK-positive NSCLC who progressed on alectinib or ceritinib: ALK in Lung Cancer Trial of brigAtinib-2 (ALTA-2). J Thorac Oncol 2022; 17: 1404-14. (Among 103 patients with refractory ALK-positive NSCLC, brigatinib [180 mg daily] induced objective responses in 26% with a median progression free survival of 3.8 months, and the most common adverse events were diarrhea [39%], CPK elevations [34%] nausea [28%] and ALT elevations [34%] but there were no serious hepatic adverse events. 36096442
Yang JC, Liu G, Lu S, He J, Burotto M, Ahn MJ, Kim DW, et al. Brigatinib versus alectinib in ALK-positive NSCLC after disease progression on crizotinib: results of phase 3 ALTA-3 trial. J Thorac Oncol 2023; 18: 1743-55. (Among 248 patients with crizotinib-refractory, ALK-positive NSCLC treated with brigatinib or alectinib, median progression free survival was similar 19 vs 19 months], while ALT elevations arose in 40% vs 36%, but no instances of clinically apparent liver injury were reported). 37574132
Buyuksimsek M, Ogul A, Yetisir AE, Duman BB, Tohumcuoglu M, Cil T, Koseci T, et al. Brigatinib-associated autoimmune hepatitis: a case report. J Oncol Pharm Pract 2026; 32: 754-6. (58 year old man with ALK- and ROS1-positive lung adenocarcinoma developed ALT elevations [353 U/L] 5 months after starting brigatinib, which decreased slightly but persisted despite stopping brigatinib but eventually improved on methylprednisolone therapy and allowed restarting the kinase inhibitor; timing of changes, liver biopsy, and Alk P and bilirubin levels not shown or not done). 37073439

## OTHER REFERENCE LINKS

1. Recent References on Brigatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Brigatinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Brigatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brigatinib)